# Linagliptin

## OVERVIEW

### Introduction

Linagliptin is a dipeptidyl peptidase-4 (DPP-4) inhibitor which is used in combination with diet and exercise in the therapy of type 2 diabetes, either alone or in combination with other oral hypoglycemic agents. Linagliptin has been linked to rare instances of clinically apparent liver injury.

### Background

Linagliptin (lin" a glip' tin) is an inhibitor of dipeptidyl peptidase-4, which is the major enzyme responsible for the degradation of glucagon-like peptide-1 (GLP-1), an important gastrointestinal hormone (incretin) that increases glucose dependent insulin secretion by the pancreas. By prolonging the effect of GLP-1, linagliptin increases insulin levels and lowers blood glucose, thereby improving glycemic control in patients with type 2 diabetes. Linagliptin was approved for use in the United States in 2011 and was the third DPP-4 inhibitor introduced into clinical practice. Its current indications are for management of glycemic control in type 2 diabetes used in combination with diet and exercise, with or without other oral hypoglycemic agents or insulin. Linagliptin is available in tablets of 5 mg under the brand name Tradjenta and in fixed combinations with metformin under the name Jentadueto and with empagliflozin under the name Glyxambi. The typical dose of linagliptin in adults is 5 to 10 mg once daily. Adverse reactions to linagliptin are not common, but may include headache, nausea, allergic reactions and rash. Hypoglycemia is uncommon with linagliptin alone (<1%), but occurs in higher rates when it is combined with other oral hypoglycemic agents. Rare, but potentially severe adverse events reported with linagliptin, as with most DPP-4 inhibitors, include pancreatitis (~0.2%), bullous pemphigoid, severe arthralgias and hypersensitivity reactions.

### Hepatotoxicity

In large clinical trials, rates of serum enzyme elevations were similar with linagliptin therapy (<1%) as with placebo, and no instances of clinically apparent liver injury were reported. Nevertheless, postmarketing experience suggests that DPP-4 inhibitors can cause hepatic enzyme elevations as well as rare instances of clinically apparent liver injury. A single case report of liver injury due to linaglitin was published in 2014. The latency to onset was 1 month and the pattern of enzyme elevations hepatocellular without immunoallergic features. Recovery was somewhat delayed and was still incomplete three months later. ANA positivity arose during recovery. Thus, linagliptin like other DPP-4 inhibitors has been linked to rare instances of acute liver injury.

Likelihood score: D (possible rare cause of clinically apparent acute liver injury).

### Mechanism of Injury

The cause of possible liver injury during linagliptin therapy is not known. The drug is mostly metabolized by the liver, largely by the cytochrome P450 system (CYP 3A4), and a toxic or immunogenic intermediate of metabolism may be produced that could cause liver injury.

### Outcome and Management

The rare instances of liver injury reported with the DPP-4 inhibitors have been self-limited and resolved rapidly with stopping the medication. The similarity in activity among the DPP-4 inhibitors suggests that there may be cross sensitivity to hepatic injury among the different agents, but this has not been reported. However, the other common antidiabetic medications in use should be tolerated without increased risk of liver injury.

References regarding the hepatotoxicity and safety of the DPP-4 inhibitors are given in the Overview section of DPP-4 Inhibitors (updated 03 January 2018).

Drug Class: Antidiabetic Agents, Incretin-Based Drugs

Other Drugs in the Subclass, Dipeptidyl Peptidase-4 (DPP-4) Inhibitors: Alogliptin, Saxagliptin, Sitagliptin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Linagliptin – Tradjenta®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Linagliptin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Linagliptin | 668270-12-0 | C25-H28-N8-O2 | Linagliptin Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Linagliptin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Linagliptin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Linagliptin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Linagliptin)